# Zinc

## OVERVIEW

### Introduction

Zinc is an essential mineral and heavy metal that is included in most over-the-counter multivitamin and mineral supplements, and is used therapeutically in higher doses because of its ability to block copper absorption as maintenance therapy of Wilson disease. Zinc has not been associated with worsening of serum enzyme elevations during therapy or with clinically apparent liver injury.

### Background

Zinc is an essential trace element that is found in many human enzymes and transcription factors. The recommended dietary allowance is 8 mg per day for women and 11 mg for men. Zinc is widely present in foods, and the typical Western diet has adequate concentrations, the highest levels being found in shellfish and red meats. Zinc deficiency is usually due to malnutrition and reduced dietary intake, but can also occur with strict vegetarian diets. Zinc deficiency is not uncommon in developing countries, but severe deficiencies are rare. Zinc deficiency can be accompanied by growth retardation, infertility, dysgeusia, diarrhea, dermatitis, glossitis, behavioral changes, depression and mental clouding. The recommended daily allowance of zinc is 15 mg per day in men and 12 mg in women, with higher levels recommended for pregnant or lactating women.

High doses of oral zinc interfere with the absorption of copper and iron, and supplementation above the RDA can cause copper deficiency. Because of its effects on copper balance, zinc has been used to treat Wilson disease, particularly as maintenance therapy once copper levels have been reduced with chelating agents. Wilson disease is a caused by inherited mutation in the ATPase7B gene, which encodes a hepatic enzyme responsible for the transmembrane transport and excretion of copper. The metabolic defect leads to accumulation of free copper in liver and blood and secondarily in other organs, particularly brain and kidney. The disease usually presents in childhood or adolescence with neurologic syndromes, signs of advanced liver disease and hemolytic anemia. Zinc is a unique approach to the treatment of Wilson disease in that it interferes with dietary absorption (probably by increasing intestinal metallothionein), rather than decreasing tissue levels by chelation. Zinc acetate is approved for use in the United States as maintenance therapy of Wilson disease and is available in capsules of 25 and 50 mg under the brand name Galzin. Other zinc formulations have been used to treat Wilson disease, including zinc sulfate and zinc gluconate (Gluzin), but these have not been formally approved for this indication. The recommended dose is 25 to 50 mg two to three times daily. Zinc when given only once daily has little or no effect on copper balance, and is not recommended. Zinc is generally well tolerated, but when given in high doses up to 10% of patients initially have abdominal pains or gastrointestinal intolerance which can require dose adjustment or discontinuation. Long term therapy can potentially lead to copper deficiency.

Zinc overdose has been described and is usually due to ingestion of coins, metallic objects or zinc soldering solutions and rarely to suicidal overdose. Symptoms include rapid onset of epigastric pain, nausea and vomiting and diarrhea, followed by lethargy, dizziness, ataxia, confusion and coma. With high doses, patients develop hypotension, metabolic acidosis and hemolytic anemia that can be severe and life-threatening. Liver injury is generally mild and arises after a day or two. Nevertheless, cases with jaundice, cholestasis and hepatic failure have been described. Therapy of acute zinc overdose generally rests upon hydration, gastric lavage or whole bowel irrigation, correction of metabolic acidosis and anemia and zinc chelation with dimercaprol or EDTA infusions.

### Hepatotoxicity

In case series and small trials of zinc therapy in patients with Wilson disease, adverse events have included gastrointestinal upset, but serum enzyme elevations and clinically apparent liver injury were not reported. Patients with Wilson disease frequently have liver injury and, in most case series, zinc therapy has been associated with slow improvement in the hepatic manifestations. Occasional patients with Wilson disease who are switched from penicillamine to zinc therapy develop mild elevations in serum aminotransferase levels, but these are more likely due to worsening control of copper balance and the underlying Wilson disease rather than direct hepatotoxicity of zinc.

Zinc overdose can be associated with liver injury, jaundice and even hepatic failure, usually arising after several days and resembling injury from copper or iron overdose. The injury is clearly direct toxicity.

Likelihood score: E (unlikely cause of clinically apparent liver injury in normal therapeutic doses).

Drug Class: Trace Elements and Metals; Chelating Agents, Wilson Disease Agents

Other Drugs in the Subclass, Wilson Disease: Dimercaprol, Penicillamine, Trientine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zinc – Generic, Galzin®

DRUG CLASS

Trace Elements and Metals; Chelating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Zinc)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Zinc | 7440-66-6 | Zn | Zn

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999; zinc is not discussed).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; agents for Wilson disease are not discussed).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1311-5. (Textbook of pharmacology and therapeutics).
Murphy JV. (1970). Intoxication following ingestion of elemental zinc. JAMA. (16 year old boy ingested 12 g of elemental zinc to help healing of a skin laceration and developed lethargy, light-headedness and ataxia which responded to hydration and dimercaprol [BAL] therapy; serum aminotransferase and bilirubin levels were normal).
Brocks A, Reid H, Glazer G. (1977). Acute intravenous zinc poisoning. Br Med J. (72 year old woman on total parenteral nutrition was given an overdose of zinc sulfate [7.4 g] and she developed hypotension, diarrhea, vomiting, oliguria and jaundice with a cholestatic pattern that slowly resolved, but she died of pneumonia 47 days later).
Stowe CM, Nelson R, Werdin R, Fangmann G, Fredrick P, Weaver G, Arendt TD. (1978). Zinc phosphide poisoning in dogs. J Am Vet Med Assoc. (Six cases of zinc toxicity in dogs due to zinc phosphide, a rodenticide, presenting with malodor, tremors, rigidity and seizures; no mention of liver injury).
Potter JL. (1981). Acute zinc chloride ingestion in a young child. Ann Emerg Med. (28 month old boy ingested 4 ounces of soldering flux [20% zinc chloride] and rapidly developed vomiting and lethargy followed by metabolic acidosis [zinc 1,644 μg/dL, AST 48 U/L, Alk P 197 U/L], recovering within 2 days with hydration and EDTA infusions).
Chobanian SJ. (1981). Accidental ingestion of liquid zinc chloride: local and systemic effects. Ann Emerg Med. (24 year old man accidentally ingested a zinc chloride solution with immediate vomiting and burning pain which resolved within 3 days with hydration and EDTA therapy; serum bilirubin and liver enzymes remaining normal).
Hornfeldt CS, Koepke TE. (1984). A case of suspected zinc toxicity in a dog. Vet Hum Toxicol.
Allen JG, Masters HG, Peet RL, Mullins KR, Lewis RD, Skirrow SZ, Fry J. (1983). Zinc toxicity in ruminants. J Comp Pathol. (In sheep and cattle, zinc toxicity can arise from use of galvanized troughs or zinc containing fertilizers or fungicides, presenting with diarrhea and vomiting, weakness and jaundice and death in severely affected animals, autopsies showing centrolobular [zone 3] hepatic necrosis).
Ulmer DD. (1977). Trace elements. N Engl J Med. (Brief review of trace elements, their metabolic roles, deficiencies and toxicities).
Hoogenraad TU, Van den Hamer CJ, Koevoet R, Korver EG. (1978). Oral zinc in Wilson's disease. Lancet. (16 year old with Wilson disease had cupruresis on penicillamine after failure during zinc therapy, although he had no clinical improvement until zinc was reintroduced).
Brewer GJ, Hill GM, Prasad AS, Cossck ZT, Rabbani P. (1983). Oral zinc therapy for Wilson’s disease. Ann Intern Med. (5 patients [25-34 years old, 3 men, 2 women] with stable Wilson disease after penicillamine therapy underwent careful copper balance studies while on zinc therapy alone, demonstrating a negative copper balance largely due to increased fecal loss).
Hoogenraad TU, Van den Hamer CJ. (1983). 3 years of continuous oral zinc therapy in 4 patients with Wilson's disease. Acta Neurol Scand. (4 patients [17 to 46 year old men] with Wilson disease previously treated with penicillamine were treated with oral zinc for at least 3 years and all showed clinical improvement and no adverse events, including no changes in liver tests during zinc therapy).
Hill GM, Brewer GJ, Juni JE, Prasad AS, Dick RD. (1986). Treatment of Wilson's disease with zinc. II. Validation of oral 64copper with copper balance. Am J Med Sci. (Assessment of copper update using a radioactive copper uptake study demonstrated that patients with Wilson disease on zinc have a low [<1%], while those on no therapy or on penicillamine or trientine had normal update levels [~6%]).
Breitschwerdt EB, Armstrong PJ, Robinette CL, Dillman RC, Karl ML, Lowry EC. (1986). Three cases of acute zinc toxicosis in dogs. Vet Hum Toxicol. (3 dogs with zinc toxicity, 2 from swallowing zinc nuts and one from licking zinc oxide ointment, presenting with vomiting, fever, pallor and jaundice with severe hemolytic anemia [bilirubin 1.7-14.9 mg/dL, ALT 143-159 U/L, Alk P 448-5400 U/L], 2 recovering and one dying of anemia and sepsis).
Torrance AG, Fulton RB. (1987). Zinc-induced hemolytic anemia in a dog. J Am Vet Med Assoc. (1 year old Yorkie developed diarrhea, vomiting, fever and “depression” with severe anemia [hematocrit 15%] after ingesting a zinc nut from his cage [bilirubin 18.9 mg/dL, Alk P 1262 U/L], recovering after endoscopic removal of object).
Hill GM, Brewer GJ, Prasad AS, Hydrick CR, Hartmann DE. (1987). Treatment of Wilson's disease with zinc. I. Oral zinc therapy regimens. Hepatology. (Copper balance studies in 14 patients with previously treated Wilson disease showed a negative copper balance while on zinc [100-150 mg daily in 2-4 separate doses] compared to high positive copper balance in 3 patients on no therapy; no adverse events noted).
Hoogenraad TU, Van Hattum J, Van den Hamer CJ. (1987). Management of Wilson’s disease with zinc sulphate: experience in a series of 27 patients. J Neurol Sci. (Among 27 Dutch patients [ages 11 to 38 years] with Wilson disease treated with zinc sulfate for periods of 1 month to 27 years, 1 died of hepatic failure within the first month, the others all improved with normalization of free serum copper levels and no adverse events).
Burkhart KK, Kulig KW, Rumack B. (1990). Whole-bowel irrigation as treatment for zinc sulfate overdose. Ann Emerg Med. (16 year old boy ingested 50 zinc sulfate tablets in a suicide attempt and was treated with emetics and whole bowel irrigation, with recovery in 2 days and no mention of liver injury or enzyme elevations).
Broun ER, Greist A, Tricot G, Hoffman R. (1990). Excessive zinc ingestion. A reversible cause of sideroblastic anemia and bone marrow depression. JAMA. (Two patients developed anemia due to zinc; a 31 year old schizophrenic man swallowed multiple coins and presented with nausea and abdominal pain with subsequent severe anemia resolving within 4 weeks; a 48 year old man on chronic zinc supplements developed fatigue and severe anemia, resolving within 2 weeks of stopping zinc intake; no mention of liver injury).
Brewer GJ, Yuzbasiyan-Gurkan V, Johnson V, Dick RD, Wang Y. (1993). Treatment of Wilson's disease with zinc XII: dose regimen requirements. Am J Med Sci. (Analysis of copper balance in 4 patients treated with 75 mg of zinc daily in 1, 2 or 3 divided doses indicated that once daily regimen did not reliably result in a negative copper balance, suggesting that zinc must be given in divided doses 2 or 3 times daily).
McKinney PE, Brent J, Kulig K. (1994). Acute zinc chloride ingestion in a child: local and systemic effects. Ann Emerg Med. (16 month old boy ingested zinc chloride soldering solution and developed vomiting and lethargy with metabolic acidosis and liver test abnormalities [bilirubin normal, ALT 123 U/L, Alk P 527 U/L], resolving within 3 days, but with severe anemia lasting a week).
Brewer GJ, Dick RD, Johnson VD, Brunberg JA, Kluin KJ, Fink JK. (1998). Treatment of Wilson's disease with zinc: XV long-term follow-up studies. J Lab Clin Med. (Description of patterns of change in urinary, hepatic and serum copper and zinc levels and liver tests in 141 patients with Wilson disease treated with zinc; adverse reactions were "minimal", the most common being initial abdominal discomfort).
Anderson LA, Hakojarvi SL, Boudreaux SK. (1998). Zinc acetate treatment in Wilson's disease. Ann Pharmacother. (Systematic review of the literature on safety and efficacy of oral zinc therapy of Wilson disease concluded that zinc acetate was effective in maintenance of copper balance in patients with Wilson disease and has negligible toxicity).
Ala A, Walker AP, Ashkan K, Dooley JS, Schilsky ML. (2007). Wilson's disease. Lancet. (Review of the clinical features, pathogenesis, genetics, diagnosis and treatment including role of zinc).
Gurnee CM, Drobatz KJ. (2007). Zinc intoxication in dogs: 19 cases (1991-2003). J Am Vet Med Assoc. (Retrospective review of 19 cases of zinc toxicosis in dogs seen over an 8 year period at one veterinary hospital; dogs presented with vomiting and lethargy with pallor and jaundice, bilirubin elevations in 80% [0.5-23 mg/dL], ALT in 7% [3-92 U/L], Alk P in 92% [107-1422 U/L] and 2 deaths [10%], source of zinc being coins, tacks and bolts).
Roberts EA, Schilsky ML. (2008). AASLD. Diagnosis and treatment of Wilson disease: an update. Hepatology. (Thorough review of the cause, natural history, diagnosis and treatment of Wilson disease, with specific recommendations for use of penicillamine, trientine and zinc).
Linn FH, Howen RH, van Hattum J, van der Kleij S, van Erpecum KJ. (2009). Long-term exclusive zinc monotherapy in symptomatic Wilson disease: experience in 17 patients. Hepatology. (Among 17 Dutch patients [ages 13 to 26] with symptomatic Wilson disease treated with zinc only for 2-30 years, most had a clinical response to treatment, but 2 patients with a neurologic presentation developed liver injury after 6 and 7 years of therapy, and 2 patients with cirrhosis initially developed liver decompensation after 15 and 24 years of therapy; the efficacy of copper elimination appeared less in those with hepatic than neurologic presentations).
Walshe JM. (2009). The conquest of Wilson's disease. Brain. (History of the initial description of Wilson disease, its link to copper accumulation, and therapies several of which were developed by the author).
Weiss KH, Stremmel W. (2012). Evolving perspectives in Wilson disease diagnosis: treatment and monitoring. Curr Gastroenterol Rep. (Review of the diagnosis and management of Wilson disease, including the role of genetic testing and the choice of medical therapies).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which was attributed to penicillamine or other agents used to treat Wilson disease).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to penicillamine but none were attributed to zinc).
Pfeiffenberger J, Beinhardt S, Gotthardt DN, Haag N, Freissmuth C, Reuner U, Gauss A, et al. (2018). Pregnancy in Wilson's disease: management and outcome. Hepatology. (Among 282 pregnancies in 136 patients with Wilson disease analyzed in a retrospective, multicenter study, spontaneous abortion was less common among patients being treated with penicillamine [17%] or zinc [10%] than untreated patients [41%], which was proportionally greater than with trientine [28%] and similar to that in patients who discontinued therapy during pregnancy [36%]; worsening of liver disease arose in some patients on treatment but was self-limiting and resolved after delivery; birth defects were found in 7 of 209 [3%] newborns overall and in 4 of 98 women taking penicillamine).
Roberts EA. (2018). Update on the diagnosis and management of Wilson disease. Curr Gastroenterol Rep. (Review of recent advances in the understanding of the pathogenesis, clinical features, diagnosis, and treatment of Wilson disease).
Appenzeller-Herzog C, Mathes T, Heeres MLS, Weiss KH, Houwen RHJ, Ewald H. (2019). Comparative effectiveness of common therapies for Wilson disease: A systematic review and meta-analysis of controlled studies. Liver Int. (Systematic review of literature on therapies of Wilson disease found no differences in outcomes with penicillamine vs zinc, but higher rates of adverse events and discontinuations with penicillamine; no mention of hepatotoxicity or ALT elevations).

## OTHER REFERENCE LINKS

1 Recent References on Zinc: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Zinc+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Zinc: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Zinc)